# Nystatin

## OVERVIEW

### Introduction

Nystatin is a topical and oral antifungal agent with activity against many species of yeast and candida albicans, which is used largely to treat skin and oropharyngeal candidiasis. Nystatin is not absorbed orally and has not been linked to drug induced liver injury.

### Background

Nystatin (nye stat' in) is a polyene macrolide antibiotic that acts by binding to sterols in the plasma membranes of fungi causing the cells to leak, eventually leading to fungal cell death. Nystatin is indicated for the treatment of candidal infections of the skin, mucous membranes and gastrointestinal tract. It is not absorbed orally and thus not indicated for invasive fungal infections. Nystatin was approved by the FDA in 1971 and is currently widely used in the treatment of superficial candida infections of the skin, mucous membranes and gastrointestinal tract, including oropharyngeal candidiasis. Nystatin is available in multiple forms such as tablets, troches, powder for suspension, creams and ointments and varying concentrations which are usually measured in units. Nystatin is available in generic forms and under brand names such as Mycostatin, Nilstat, Nystat and Nystop. The recommended dose for oropharyngeal candidiasis is 500,000 to 1,000,000 units 3 to 5 times daily as oral suspension or tablets (dissolved in the mouth) for 1 to 2 weeks. Common side effects include metallic taste, dry mouth, anorexia and nausea.

### Hepatotoxicity

Nystatin therapy has been associated with a low rate of serum enzyme abnormalities, although it has been difficult to attribute these elevations to nystatin. Despite its use for several decades, there have been no convincing cases of acute hepatic injury linked to nystatin therapy. While nystatin is usually is not normally absorbed, low concentrations may enter the circulation in patients with inflammation and damage to the gastrointestinal tract. Nevertheless, nystatin is considered very safe and is unlikely to cause hepatic injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The absence of hepatotoxicity from nystatin is probably largely due to lack of absorption.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nystatin – Generic, Mycostatin®, Nystat®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nystatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nystatin | 1400-61-9 | C46-H83-N-O18 C47-H75-N-O17

## ANNOTATED BIBLIOGRAPHY

References updated: 30 April 2020

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999; nystatin is considered safe because it is not absorbed).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents does not discuss nystatin).
Rogers PD, Krysan DJ. Antifungal agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1087-104. (Textbook of pharmacology and therapeutics).
Pons V, Greenspan D, Lozada-Nur F, McPhail L, Gallant JE, Tunkel A, Johnson CC, et al. (1997). Oropharyngeal candidiasis in patients with AIDS: randomized comparison of fluconazole versus nystatin oral suspensions. Clin Infect Dis. (Controlled trial of 2 weeks of nystatin vs fluconazole in 167 patients with HIV infection and oropharyngeal candidiasis; side effects were minimal and included liver enzyme elevations in 2 subjects on fluconazole, but none on nystatin).
Pons V, Greenspan D, Debruin M. (1993). Therapy for oropharyngeal candidiasis in HIV-infected patients: a randomized, prospective multicenter study of oral fluconazole versus clotrimazole troches. The Multicenter Study Group. J Acquir Immune Defic Syndr. (Trial of 14 days of fluconazole vs clotrimazole in 334 HIV infected patients with oropharyngeal candidiasis; 2 patients on fluconazole but none of clotrimazole were withdrawn for serum ALT elevations).
Flynn PM, Cunningham CK, Kerkering T, San Jorge AR, Peters VB, Pitel PA, Harris J, et al. (1995). Oropharyngeal candidiasis in immunocompromised children: a randomized, multicenter study of orally administered fluconazole suspension versus nystatin. The Multicenter Fluconazole Study Group. J Pediatr. (Controlled trial of 14 days of fluconazole vs nystatin in 182 children with oropharyngeal candidiasis; liver test abnormalities occurred in 8% on nystatin vs 7% on fluconazole; no early discontinuations because of abnormalities).
Young GA, Bosly A, Gibbs DL, Durrant S. (1999). A double-blind comparison of fluconazole and nystatin in the prevention of candidiasis in patients with leukaemia. Antifungal Prophylaxis Study Group. Eur J Cancer. (Controlled trial of nystatin vs fluconazole for prevention of fungal infections in 160 patients with leukemia on chemotherapy; ALT elevations occurred in 24% of nystatin vs 24% of fluconazole treated patients, but most were attributed to other causes; one patient in each group developed “hepatitis”).
(2001). Drugs for vulvovaginal candidiasis. Med Lett Drugs Ther. (Concise summary of agents approved for therapy of vulvovaginal candidiasis including topical nystatin and the “azoles” such as clotrimazole, miconazole and butoconazole and oral fluconazole, mentions that nystatin is less effective than the azoles and that a single oral dose of fluconazole is often preferred by patients).
(2009). Antifungal drugs. Treat Guidel Med Lett. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; nystatin is listed as a topical antifungal agent, but is not discussed).
Pienaar ED, Young T, Holmes H. (2010). Interventions for the prevention and management of oropharyngeal candidiasis associated with HIV infection in adults and children. Cochrane Database Syst Rev. (Metaanalysis of trials comparing different regimens of therapy for oropharyngeal candidiasis; does not discuss hepatotoxicity).
(2012). Antifungal drugs. Treat Guidel Med Lett. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; nystatin is listed as a topical antifungal agent, but is not discussed).
Pankhurst CL. (2013). Candidiasis (oropharyngeal). BMJ Clin Evid. (Review of the evidence for efficacy of pharmacologic prevention and treatment or oropharyngeal candidiasis concludes that nystatin is less effective than oral and topical azole therapies but adverse events are uncommon; no mention of hepatotoxicity of nystatin).
Mersal A, Alzahrani I, Azzouz M, Alsubhi A, Alsawaigh H, Albshri N, Bajammal M, et al. (2013). Oral nystatin versus intravenous fluconazole as neonatal antifungal prophylaxis: non-inferiority trial. J Clin Neonatol. (Among 57 premature neonates treated with oral nystatin or intravenous fluconazole [every 48-72 hours] for 6 weeks, none developed invasive candida infections and detection of candida in rectal swabs was uncommon in both groups; serum ALT levels were higher in those who received fluconazole but were all in the normal range).
Fan S, Liu X, Wu C, Xu L, Li J. (2015). Vaginal nystatin versus oral fluconazole for the treatment for recurrent vulvovaginal candidiasis. Mycopathologia. (Among 293 women with recurrent vulvovaginal candidiasis treated with vaginal nystatin suppositories for 14 days monthly or oral fluconazole [150 mg] once weekly, initial and 6 month follow up cure rates were similar in the two groups, and only one patient was intolerant of vaginal nystatin [burning and pain] and required switching to fluconazole).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 [1.6%] were attributed to an antifungal agent, but none to nystatin).
Lyu X, Zhao C, Yan ZM, Hua H. (2016). Efficacy of nystatin for the treatment of oral candidiasis: a systematic review and meta-analysis. Drug Des Devel Ther. (Systematic review of the published literature on the efficacy and safety of nystatin therapy for oral candidiasis identified 11 trials in 1148 patients [dental, pediatric, HIV-AIDS, cancer and miscellaneous groups], with cure rates of 14-77%; adverse events being reported in 8 studies common mentioned change in taste, and less commonly nausea, vomiting, diarrhea, anorexia and abdominal pain; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Nystatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(nystatin)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nystatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nystatin)